# Dantrolene

## OVERVIEW

### Introduction

Dantrolene is a muscle relaxant used for treatment of chronic spasticity that differs from other commonly used muscle relaxants in acting peripherally on muscle, rather than centrally on the spinal cord or brain. Dantrolene can cause acute liver injury which can be severe and even fatal.

### Background

Dantrolene (dan' troe leen) is a lipid soluble diphenylhydantoin analogue that inhibits muscle contractions by decreasing the release of calcium from the sarcoplasmic reticulum in target tissue. Dantrolene is used for the treatment of chronic spasticity and treatment for and prophylaxis against malignant hyperthermia (based upon its ability to block calcium release, which is the initiating event in malignant hyperthermia). Dantrolene was approved for use in the United States in 1974 and is still commonly used for spasticity. Dantrolene is available as capsules of 25, 50 and 100 mg in several generic forms and under the commercial name Dantrium. In adults, the recommended initial dose for spasticity is 25 mg daily, with subsequent increases to a dose of 25 to 100 mg three times daily. Dantrolene is also available in parenteral formulations for therapy of acute episodes of malignant hyperthermia; the recommended initial dose being 1 mg/kg intravenously. For prophylaxis against hyperthermia, dantrolene is given orally in doses of 4 to 8 mg/kg daily. Common side effects include weakness, nausea, drowsiness, fatigue and dizziness.

### Hepatotoxicity

Mild, asymptomatic serum aminotransferase elevations during dantrolene therapy are relatively uncommon (1%), but clinically over liver injury is estimated to occur in 1 to 2 per thousand treated persons (0.1% to 0.2%). The liver injury can be severe; cases of acute liver failure and even death have been described (Case 1). The latency to onset of clinically apparent liver injury ranges from one week to several months, but is usually within the first 6 months of starting therapy (Case 2). More serious cases are associated with a sudden onset with jaundice, nausea and fatigue, and rapid progression. Allergic manifestations such as fever, rash and eosinophilia are rare, as are autoimmune features. The pattern of enzyme elevations is predominantly hepatocellular. Liver histology demonstrates an acute-hepatitis like picture. Recovery is usually complete within 1 to 3 months. Women, the elderly, and patients taking higher doses appear to be more susceptible to developing dantrolene hepatotoxicity.

Likelihood score: A (Well established cause of clinically apparent liver injury).

### Mechanism of Injury

Dantrolene is structurally similar to phenytoin, which is a well known cause of idiosyncratic acute liver injury; thus, two agents may share a similar mechanism of hepatic injury. However, dantrolene rarely causes immunoallergic hepatitis (which is typical of phenytoin) and cases of more severe injury are associated with taking higher doses of dantrolene, suggesting the presence of a toxic metabolite.

### Outcome and Management

Cases of acute hepatitis with jaundice due to dantrolene can be severe and even fatal; however, most cases are followed by complete recovery within 1 to 3 months of stopping the medication. Cases of chronic hepatitis or bile duct vanishing syndrome have not been reported. Rechallenge results in recurrence and should be avoided. There is at least a theoretical concern of cross sensitivity with phenytoin, but other drugs for spasticity should be tolerated without recurrence of liver injury.

Drug Class: Muscle Relaxants

## CASE REPORTS

### Case 1. Fatal progressive liver disease after a 12 week course of dantrolene.

[Modified from: Cornette M, Gillard C, Borlee-Hermans G. (Fatal toxic hepatitis associated with administration of dantrolene.) Acta Neurol Belg 1980; 80: 336-47. French. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7468146)]

A 50 year old woman with diabetes and multiple sclerosis was given dantrolene for spasticity and developed jaundice 12 weeks later. She began complaining of nausea, poor appetite, and weight loss after 7 weeks of therapy, but dantrolene was continued and she had lost 13 kilograms of weight and developed jaundice before the drug was stopped. She had no history of liver disease or exposure to hepatitis and did not drink alcohol. On admission, she was mildly jaundiced and laboratory tests showed mild elevations in serum ALT and alkaline phosphatase (Table). There was no fever or rash. Tests for viral hepatitis and autoantibodies were negative. Cholangiography was negative as was a CT scan of the liver. Nevertheless, she underwent exploratory laparotomy. Intraoperative liver biopsy showed intrahepatic cholestasis and mixed cellular injury suggestive of drug induced liver disease. She deteriorated postoperatively with progressive jaundice, ascites, and hepatic encephalopathy, dying of multiorgan failure 2 weeks after surgery.

#### Key Points

Medication: | Dantrolene (400 mg daily)
Pattern: | Mixed (R=~2.1)
Severity: | 5+ (death)
Latency: | 95 days
Recovery: | None
Other medications: | Not mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
-1 month | | 20 | 75 | 0.5
0 | | Start Dantrolene
1 month | | 33 | 147
2 months | | | | | Onset of symptoms
3 months | 0 | 57 | 175 | 2.0 | Jaundice, dantrolene stopped
| 17 days | 73 | 135 | 9.0 | Exploratory laparotomy
| 24 days | 214 | 123 | 25.0 | Ascites, encephalopathy
| 31 days | 159 | 414 | 35.0
4 months | 32 days | Death
Normal Values | | <42 | <115 | <1.2

#### Comment

This patient was continued on dantrolene despite symptoms of liver disease for several weeks and, perhaps as a consequence, had a progressive downhill course with worsening jaundice and hepatic synthetic dysfunction. Also unfortunate, was the unnecessary laparotomy and general anesthesia which may have worsened the liver injury. Somewhat unusual in this case was the minimal elevations in serum ALT at presentation, but there may have been more marked elevations earlier in the symptomatic course before clinical evaluation.

### Case 2. Acute hepatitis from dantrolene with recurrence on rechallenge.

[Modified from: Ogburn RM, Myers RL, Burdick GE. Hepatitis associated with dantrolene sodium. Ann Intern Med 1976; 84: 53-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1244796)]

A 26 year old man with Friedreich's ataxia with spasticity and dysarthria was started on dantrolene in a dose of 25 mg four times daily. After 10 days, his dysarthria worsened and dantrolene was stopped. Serum enzymes were reported to be normal. One year later, dantrolene was restarted and he again experienced worsening dysarthria and stopped the medication after 10 days. Over the course of the following month, he had the insidious onset of malaise, nausea, dark urine and light stools. When found to be jaundiced, he was admitted for evaluation. He denied a history of liver disease and exposure to viral hepatitis or other toxins. Total bilirubin was 4.6 mg/dL, AST 740 U/L, but alkaline phosphatase was normal (Table). Tests for viral hepatitis and autoantibodies were negative. He had no rash, fever or eosinophilia. He improved rapidly and was discharged. Two months after recovering, he was restarted on dantrolene by another physician. His dysarthria worsened and, for the third time, he stopped the medication after 10 days. The day after stopping therapy, serum AST was 115 U/L and bilirubin was slightly elevated. During the next few weeks, he developed clinically apparent acute liver injury and was admitted. Laboratory tests again showed no evidence of viral hepatitis or autoimmune liver condition. A liver biopsy showed an acute hepatitis-like picture with prominence of eosinophils in portal areas. Over the next two weeks, the patient recovered and was discharged. Two weeks later he was clinically well and serum AST had fallen to 96 U/L.

#### Key Points

Medication: | Dantrolene (100 mg daily)
Pattern: | Hepatocellular (ALT without Alk P elevations)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Initially, ~33 days from starting, 23 days after stopping the drug. On rechallenge, ~11 days from starting, 1 day after stopping
Recovery: | Complete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
10 days | 0 | Dantrolene stopped due to dysarthria
33 days | 23 days | Malaise, nausea, vomiting, pale stools
42 days | 32 days | 740 | 106 | 4.6 | Jaundice
43 days | 34 days | 500 | | | Discharged
68 days | 58 days | 52 | | 1.6
Time After Restarting | Time After Stopping Again | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Dantolene Restarted
10 days | 0 | Dantrolene stopped because of worsening dysarthria
11 days | 1 day | 115 | | 2.1 | Jaundice
24 days | 2 weeks | 1150 | | 4.5 | Acute hepatitis like symptoms
4 weeks | 3 weeks | | | | Biopsy
6 weeks | 5 weeks | 96
Normal Values | | <42 | <115 | <1.2

#### Comment

The recurrence of an acute hepatitis-like syndrome with rechallenge and similarity of the two episodes with a shortening of the latency on second exposure is strongly supportive of the role of dantrolene in causing the acute hepatitis-like liver injury. Somewhat unusual was the worsening of the liver injury for several weeks after dantrolene was stopped. Dantrolene, by inhibiting calcium release from the sarcoplasmic reticulum, can also cause generalized weakness which may account for the dysarthria that this patient experienced with each exposure to dantrolene. By limiting the duration of therapy, the dysarthria probably spared him a more severe hepatic injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dantrolene – Generic, Dantrium®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=dantrolene)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Dantrolene | 7261-97-4 | C14-H10-N4-O5 | Dantrolene chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999 mentions that dantrolene causes overt liver injury in 0.4% of recipients, which is usually hepatocellular and sometimes fatal).
Chyatte SB, Birdsong JH. The use of dantrolene sodium in disorders of the central nervous system. South Med J 1971; 64: 830-4. (Among 30 patients treated with dantrolene long term, 3 developed transient AST elevations but none were considered clinically significant). 4933014
Herman R, Mayer N, Mecomber SA. Clinical pharmaco-physiology of dantrolene sodium. Am J Phys Med 1972; 51: 296-311. (Study of effects of dantrolene on neuromuscular activity in humans; no mention of adverse effects). 4564128
Mayer N, Necomber SA, Herman R. Treatment of spasticity with dantrolene sodium. Am J Phys Med 1973; 52:18-29. (A study of efficacy and safety of dantrolene; one patient with alcoholic cirrhosis had mild ALT and AST elevations that resolved with stopping and recurred with restarting drug). 4685519
Joynt RL. Dantrolene sodium: long-term effects in patients with muscle spasticity. Arch Phys Med Rehabil 1976; 57: 212-7. (Among 77 patients treated with dantrolene for up to 2 years, 3 had AST elevations and one developed jaundice after 2 months and died one week later apparently of liver failure). 776122
Ogburn RM, Myers RL, Burdick GE. Letter: Hepatitis associated with dantrolene sodium. Ann Intern Med 1976; 84: 53-4. (26 year old man developed acute hepatitis like syndrome 43 days after starting dantrolene [bilirubin 4.6 mg/dL, ALT 740 U/L, Alk P 106 U/L], resolving in a few weeks; recurrence with latency of 11 days on reexposure [Case 2]). 1244796
Schneider R, Mitchell D. Dantrolene hepatitis. JAMA 1976; 235:1590-1. (38 year old woman with spasticity developed jaundice 16 weeks after starting escalating doses of dantrolene [bilirubin 9.0 rising to 32.8 mg/dL, AST 258 U/L, Alk P 215 U/L], resolving within 3 months of stopping). 946274
Assatourians P. Dantrolene hepatitis. JAMA 1976; 236: 1351. (Letter in response to Schneider [1976] arguing that a liver biopsy rather than ERCP was the diagnostic procedure of choice: "Any student of hepatology knows..."). 989080
Pinder RM, Brogden RN, Speight TM, Avery GS. Dantrolene sodium: a review of its pharmacological properties and therapeutic efficacy in spasticity. Drugs 1977; 13: 3-23. (Review of efficacy and safety of dantrolene; minor abnormalities in AST occur in 10% of patients and hepatitis in 0.35-0.5%). 318989
Utili R, Boitnott JK, Zimmerman HJ. Dantrolene-associated hepatic injury. Incidence and character. Gastroenterology 1977; 72 (4 Pt 1): 610-6. (A study of dantrolene safety based upon 2191 patients treated for at least 60 days; 1.8% developed evidence of hepatic injury, 0.6% jaundice and 0.3% died: about 1% had to stop due to hepatotoxicity and 2 of 5 who were restarted had a recurrence; recovery time ranged from 1 to 12 months and women were more likely to have liver injury than men; analysis of ~30,000 patients taking long term dantrolene revealed 31 physician reported cases of hepatoxicity [0.1%], 16 [52%] being jaundiced and 11 [35%] fatal). 838213
Wilkinson SP, Portmann B, Williams R. Hepatitis from dantrolene sodium. Gut 1979; 20: 33-6. (Description of 1 man and 3 women [ages 45 to 80 years] who developed hepatotoxicity 1 to 3 months after starting dantrolene [bilirubin normal to 19 mg/dL, AST 137 to 800 U/L, Alk P 117 to 345 U/L], liver biopsy revealed acute hepatitis with focal or bridging necrosis, recovery in 4 to 12 weeks). 761834
Cornette M, Gillard C, Borlee-Hermans G. [Fatal toxic hepatitis associated with administration of dantrolene (author's transl)] Acta Neurol Belg 1980; 80: 336-47. French. (50 year old woman developed nausea, weight loss, and jaundice 3 months after starting dantrolene [bilirubin 2.0 rising to 35 mg/dL, ALT 57-214 U/L and Alk P 175-414 U/L], undergoing cholecystectomy and dying of sepsis and shock several days later [Case 1]). 7468146
Arnold TH Jr, Epps JM 3rd, Cook HR, Hamrick ME. Dantrolene sodium: urinary metabolites and hepatotoxicity. Res Commun Chem Pathol Pharmacol 1983; 39: 381-98. (Animal study showing dose related hepatotoxicity of dantrolene in mice). 6856946
Durham JA, Gandolfi AJ, Bentley JB. Hepatotoxicological evaluation of dantrolene sodium. Drug Chem Toxicol 1984; 7: 23-40. (Animal study showing no hepatotoxicity of dantrolene in mice). 6723545
Sorensen EM, Acosta D. Comparison of dantrolene sodium with erythromycin estolate using primary cultures of rat hepatocytes. Drug Chem Toxicol 1985; 8: 219-37. (Erythromycin, but not dantrolene, caused injury to primary rat hepatocytes). 4075997
Chan CH. Dantrolene sodium and hepatic injury. Neurology. 1990; 40: 1427-32. (Review of 122 cases of dantrolene hepatotoxicity reported to manufacturer; 59 with symptoms, 36 jaundice and 27 fatal; most arising within first 6 months, but fatal cases often late; mean ALT 784 U/L, Alk P 2-3 times ULN). 2392230
Tolman KG. Hepatotoxicity of antirheumatic drugs. J Rheumatol Suppl 1990; 22: 6-11. (Review of hepatotoxicity of antirheumatic drugs including dantrolene). 2192059
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to dantrolene or other muscle relaxants). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one was attributed to chlorzoxazone, but none to dantrolene or other muscle relaxants). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to dantrolene). 20949552
Kim JY, Chun S, Bang MS, Shin HI, Lee SU. Safety of low-dose oral dantrolene sodium on hepatic function. Arch Phys Med Rehabil 2011; 92: 1359-63. (Retrospective analysis of liver test results from 243 patients treated with dantrolene for 4 weeks or more; one patient, an HBsAg carrier, developed elevations in liver tests without symptoms 82 days after starting dantrolene [bilirubin rising from 0.5 to 2.5 mg/dL, AST 54 to 85 U/L, Alk P 167 to 245 U/L], which resolved on stopping). 21878205
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to dantrolene or other muscle relaxants). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to dantrolene or other muscle relaxants). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants including 2 to dantrolene). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Dantrolene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dantrolene/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dantrolene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dantrolene)